# Dipyridamole

## OVERVIEW

### Introduction

Dipyridamole is a vasodilator and inhibitor of platelet aggregation that is used to decrease the risk of thromboembolic complications and recurrence of stroke in patients known to have atherosclerotic cerebrovascular disease. Dipyridamole is associated with a low rate of serum enzyme elevations during treatment, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Dipyridamole (dye' pir id' a mole) is a pyrimidine analogue that is used as an antiplatelet agent to decrease the risk of thromboembolic complications in patients at high risk, such as with a prosthetic heart value, with hypercoagulable states and with a history of arterial thromboses (heart attack, stroke). Dipyridamole is usually given in combination with other anticoagulants or antiplatelet agents such as warfarin or aspirin. Dipyridamole was approved for use in the United States in 1961 as an adjunct to coumarin anticoagulants in prevention of thromboembolic complications of cardiac valve replacements. Dipyridamole is available in tablets of 25, 50 and 75 mg in generic forms and under the trade name Persantine. It is also available in fixed combinations with aspirin under the name Aggrenox as prophylaxis to reduce the risk of stroke in patients with previous history of ischemic stroke or transient ischemic attacks. The typical recommended dose varies by indication, but for adults is generally 150 to 400 mg daily in divided doses. Dipyridamole is also available as a solution for injection for use as an alternative to exercise in thallium myocardial perfusion imaging (“dipyridamole stress test”). Dipyridamole is generally well tolerated, but side effects can include headache, dizziness, flushing, chest pain, gastrointestinal upset, nausea, diarrhea, rash and pruritus.

### Hepatotoxicity

Dipyridamole has been associated with a low rate of serum enzyme elevations during therapy, but in large clinical trials the frequency of liver enzyme abnormalities was similar with dipyridamole therapy as with placebo. Cases of clinically apparent acute liver injury from dipyridamole have not been published although hepatitis is listed as a potential side effect in the product label. The clinical features of the liver injury linked to dipyridamole have not been described.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Cangrelor, Clopidogrel, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dipyridamole – Generic, Persantine®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dipyridamole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dipyridamole | 211914-51-1 | C25-H25-N7-O3 | Dipyridamole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 January 2018

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999; mentions that there are no published cases of hepatic injury associated with dipyridamole).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents including antiplatelet drugs; dipyridamole is not discussed).
Weitz JI. Antiplatelet drugs. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 868-72. (Textbook of pharmacology and therapeutics).
Picano E; PISA (Persantin In Stable Angina) study group. Dipyridamole in chronic stable angina pectoris; a randomized, double blind, placebo-controlled, parallel group study. Eur Heart J 2001; 22: 1785-93. (Among 400 patients with stable angina treated with dipyridamole vs placebo, headache [25% vs 6%], diarrhea [14% vs 6.5%], and nausea [5.6% vs 1.5%] were more frequent among dipyridamole treated patients; no mention of liver adverse events or ALT levels). 11549300
Humphreys DM, Street J, Schumacher H, Bertrand-Hardy JM, Palluk R. Dipyridamole may be used safely in patients with ischaemic heart disease. Int J Clin Pract 2002; 56: 121-7. (Review of cardiac adverse events during therapy with dipyridamole indicates no evidence of increased risk). 11926699
Babaoglu MO, Karadag O, Saikawa Y, Altundag K, Elkiran T, Yasar U, Bozkurt A. Hepatotoxicity due to a possible interaction between cytosine arabinoside and dipyridamole: a case report. Eur J Clin Pharmacol 2004; 60: 455-6. (52 year old man with acute myeloblastic leukemia in relapse received an induction regimen while also on dipyridamole and developed jaundice with little change in serum enzyme levels, dying a few days later of septicemia; authors suggested a drug-drug interaction between dipyridamole and cytosine arabinoside). 15232664
ESPRIT Study Group, Halkes PH, van Gijn J, Kappelle LJ, Koudstaal PJ, Algra A. Aspirin plus dipyridamole versus aspirin alone after cerebral ischaemia of arterial origin (ESPRIT): randomised controlled trial. Lancet 2006; 367 (9523): 1665-73. (Among 2739 patients treated with dipyridamole/aspirin or aspirin alone after mild stroke or transient ischemic attack, headache was major reason for discontinuation of dipyridamole; no mention of liver adverse events). 16714187
Sacco RL, Diener HC, Yusuf S, Cotton D, Ounpuu S, Lawton WA, Palesch Y, et al.; PRoFESS Study Group. Aspirin and extended-release dipyridamole versus clopidogrel for recurrent stroke. N Engl J Med 2008; 359: 1238-51. (Controlled trial of dipyridamole/aspirin vs clopidogrel in 20,332 patients with history of stroke followed for an average of 2.5 years; hepatobiliary adverse events occurred in 0.8% on dipyridamole/aspirin vs 0.9% on clopidogrel, but did not account for any of the early discontinuations or deaths). 18753638
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to antiplatelet agents). 18955056
Previtera AM, Pagani R. Agranulocytosis and hepatic toxicity with ticlopidine therapy: a case report. J Med Case Reports 2010; 4: 269. (70 year old woman developed agranulocytosis [neutrophils 100/L] 4 weeks after starting ticlopidine, with abnormal liver tests [bilirubin normal, ALT 560 U/L, Alk P 821 U/L, GGT 449 U/L], resolving within 4 weeks of stopping [and switching to dipyridamole and aspirin]). 20704700
Bath PM, Cotton D, Martin RH, Palesch Y, Yusuf S, Sacco R, Diener HC, et al.; PRoFESS Study Group. Effect of combined aspirin and extended-release dipyridamole versus clopidogrel on functional outcome and recurrence in acute, mild ischemic stroke: PRoFESS subgroup analysis. Stroke 2010; 41: 732-8. (Among 1360 patients treated with either clopidogrel or dipyridamole/aspirin with 72 hours of a stroke, serious adverse events were low and similar between the two groups; no mention of hepatic adverse events). 20181679
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to dipyridamole). 25754159
Sun Q, Chang S, Lu S, Zhang Y, Chang Y. The efficacy and safety of 3 types of interventions for stroke prevention in patients with cardiovascular and cerebrovascular diseases: a network meta-analysis. Clin Ther 2017; 39: 1291-312.e8. (Metaanalysis of the efficacy and safety of drugs for stroke prevention including dipyridamole; does not mention ALT elevations or hepatotoxicity). 28606562
Bath PM, Woodhouse LJ, Appleton JP, Beridze M, Christensen H, Dineen RA, Duley L, et al.; TARDIS Investigators. Antiplatelet therapy with aspirin, clopidogrel, and dipyridamole versus clopidogrel alone or aspirin and dipyridamole in patients with acute cerebral ischaemia (TARDIS): a randomised, open-label, phase 3 superiority trial. Lancet 2017 Dec 20. pii:S0140-6736(17)32849-0. [Epub ahead of print] (Among 3096 patients with recent ischemic stroke or transient ischemic attack treated with aspirin, clopidogrel and dipyridamole together or clopidogrel alone or dispyridamole with aspirin, the incidence of recurrent stroke at 90 days was similar in all groups, but bleeding adverse events were more common with the combination of all 3 drugs; no mention of ALT elevations or hepatotoxicity). 29274727

## OTHER REFERENCE LINKS

1. Recent References on Dipyridamole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dipyridamole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dipyridamole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dipyridamole)